# Praziquantel

## OVERVIEW

### Introduction

Praziquantel is an anthelmintic agent with activity against a broad spectrum of trematodes and cestodes that is used predominantly in the therapy of schistosomiasis, liver flukes, and cysticercosis. Praziquantel therapy has been reported to cause serum aminotransferase elevations during therapy, but clinically apparent liver injury after its use is rare if it occurs at all.

### Background

Praziquantel (praz" i kown' tel) is a heterocyclic prazino-isoquinoline derivative with a broad spectrum of activity against several trematodes (Fasciola, Schistosoma) and cestodes (Taenia). Praziquantel is believed to act by interference with tegument calcium transport, resulting in paralysis of the parasitic worms with subsequent loss of adherence to tissue, degradation and expulsion. Praziquantel was approved for use in the United States in 1982 for schistosomiasis and subsequently for clonorchiasis. Praziquantel is also commonly used in veterinary medicine. Praziquantel is available for human use in tablets of 600 mg generically and under the brand name Biltricide. The typical dose for treating schistosomiasis in adults is 20 mg/kg (depending upon the species) three times over one day. The dose for treating clonorchiasis is 25 mg/kg three times over one day. Side effects are common but transient, and include abdominal discomfort, nausea, vomiting, vertigo, muscle aches, drowsiness, headaches and fatigue, some of the symptoms being due to its effects on the parasites. Serious adverse events include transient clinical deterioration, cardiac arrhythmias, hypersensitivity reactions and rash.

### Hepatotoxicity

Praziquantel therapy has been associated with elevations in serum aminotransferase levels in up to 27% of patients, but these abnormalities were self-limiting. Praziquantel has been rarely associated with clinically apparent liver injury, which generally accompanied hypersensitivity reactions such as rash and fever. In a large retrospective survey from China, 2 of 25,000 treated patients were reported to have developed jaundice after praziquantel therapy, but no specific information about the two cases was provided. There have been few studies of long term therapy with praziquantel, and most controlled trials of this agent have used one day courses without serum aminotransferase monitoring. However, millions of people have been treated with praziquantel as a part of large scale control strategies in China where schistosomiasis Japonica is endemic. The combination of praziquantel preventive therapy and snail control has resulted in marked decreases in the prevalence of infection in the population with no evidence of significant toxicity. Thus, mild acute liver injury can accompany systemic hypersensitivity reactions to praziquantel, but both the allergic reaction and the liver injury tend to be short-lived and resolve rapidly even without specific therapy.

Likelihood score: D (possible rare cause of clinically apparent liver injury usually as a part of a systemic hypersensitivity reaction).

### Mechanism of Injury

Praziquantel is extensively metabolized by the liver via the cytochrome P450 system and might cause hepatic injury as a result of a toxic intermediate of its metabolism. Plasma levels of praziquantel are affected by inducers (rifampin decreases drug levels) and inhibitors of P450 activity (cimetidine, ketoconazole and erythromycin can reduce drug levels).

### Outcome and Management

Praziquantel is usually well tolerated and clinically apparent liver injury due to its use is rare. There is no evidence for cross sensitivity to other anthelmintic agents.

Drug Class: Anthelmintic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Praziquantel – Biltricide®

DRUG CLASS

Anthelmintic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=praziquantel)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Praziquantel | 55268-74-1 | C19-H24-N2-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2020

Zimmerman HJ. Antihelminthics. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 626-8. (Expert review of hepatotoxicity of anthelmintics written in 1999; praziquantel has been reported to cause serum aminotransferase elevations).
Keiser J, McCarthy J, Hotez P. Chemotherapy of helminth infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1001-9. (Textbook of pharmacology and therapeutics).
Chen MG, Fu S, Hua XJ, Wu HM. (1983). A retrospective survey on side effects of praziquantel among 25,693 cases of schistosomiasis Japonica. Southeast Asian J Trop Med Public Health. (Retrospective survey of side effects after a 1-2 day course of praziquantel for Schistosomiasis in 25,693 patients from China; 2 patients developed jaundice 1-5 days after treatment, both resolving within 2 weeks; 2 other patients with advanced liver disease had acute decompensation shortly after therapy; no details given).
Matthaiou DK, Panos G, Adamidi ES, Falagas ME. (2008). Albendazole versus praziquantel in the treatment of neurocysticercosis: a meta-analysis of comparative trials. PLoS Negl Trop Dis. (Systematic review of efficacy of albendazole versus praziquantel; mentions that there were no differences in rates of adverse events, but no details given).
Yangco BG, De Lerma C, Lyman GH, Price DL. (1987). Clinical study evaluating efficacy of praziquantel in clonorchiasis. Antimicrob Agents Chemother. (Controlled trial of praziquantel vs placebo in 42 patients with clonorchiasis treated for one day twice 30 days apart; side effects included nausea, vomiting and dizziness, but there were no increases in ALT levels).
Seo BS, Lee SH, Chai JY, Hong ST. (1983). Praziquantel(Distocide®) In treatment of Clonorchis Sinensis infection. Kisaengchunghak Chapchi. (Among 55 Korean patients with liver flukes treated with praziquantel [75 mg/kg over one day], none developed clinical liver injury and average serum AST levels did not change).
Ross AG, Sleigh AC, Li Y, Davis GM, Williams GM, Jiang Z, Feng Z, McManus DP. (2001). Schistosomiasis in the People's Republic of China: prospects and challenges for the 21st century. Clin Microbiol Rev. (Review of the burden of schistosomiasis japonica infections in China and approaches to treatment and prevention including use of praziquantel in the general population).
Shen C, Choi MH, Bae YM, Yu G, Wang S, Hong ST. (2007). A case of anaphylactic reaction to praziquantel treatment. Am J Trop Med Hyg. (35 year old man with clonorchiasis developed dizziness, urticaria, dyspnea, palpitations and nausea after a single dose of praziquantel with abnormal aminotransferase levels [ALT 81 U/L, AST 132 U/L], symptoms resolving within a few days).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease collected in the US between 2003 and 2008, none were attributed to an anthelmintic agent).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to anthelmintic agents).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, there were no anthelmintic agents listed among the top 40 implicated medications).
(2013). Drugs for parasitic infections. Treat Guidel Med Lett. (Brief description of drugs for parasitic infections in adults and children as well as a table of their major side effects; praziquantel is the drug of choice for schistosomiasis, liver flukes [Clonorchis sinensis and others], and intestinal tapeworm; side effects can include abdominal pain, diarrhea, fatigue, nausea, drowsiness, fever and rash).
Wu W, Huang Y. (2013). Application of praziquantel in schistosomiasis japonica control strategies in China. Parasitol Res. (Summary of results of approaches to decreasing schistosomiasis japonica infection in China with discussion of success and safety of praziquantel prophylaxis in the general population; no mention of hepatotoxicity).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to an anthelmintic, mebendazole; none were attributed to praziquantel).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 409 [46%] were attributed to antimicrobial agents, but none to anthelmintics or to praziquantel).
Qian MB, Utzinger J, Keiser J, Zhou XN. (2016). Clonorchiasis. Lancet. (Review of the life cycle, epidemiology, clinical course and complications of Clonorchis sinensis infection mentions that praziquantel is the treatment of choice and is used in mass prevention and is highly effective with only transient and mild adverse events; no mention of liver test abnormalities).
Gassiep I, Clark PJ, McManus DP, Looke DL. (2016). Hepatobiliary and pancreatic: Acute hepatitis in the setting of chronic Schistosoma mansoni infection and post-praziquantel therapy. J Gastroenterol Hepatol. (19 year old man with hepatomegaly [bilirubin 3.0 mg/dL, ALT 1220 U/L, Alk P 331 U/L] and stool tests showing S. mansoni had delayed but ultimately full resolution of liver test abnormalities after praziquantel therapy).
Gong Z, Xu Z, Lei C, Wan C. (2017). Hepatic paragonimiasis in a 15-month-old girl: a case report. BMC Pediatr. (15 month old female with fever and hepatomegaly and multiple low density hepatic lesions had hepatic paragonimiasis on liver biopsy and resolution after 3 days of praziquantel therapy).
Sayasone S, Keiser J, Meister I, Vonghachack Y, Xayavong S, Senggnam K, Phongluxa K, et al. (2018). Efficacy and safety of tribendimidine versus praziquantel against Opisthorchis viverrini in Laos: an open-label, randomised, non-inferiority, phase 2 trial. Lancet Infect Dis. (Among 607 children with O. viverrini liver fluke infection treated with tribendimidine or praziquantel, cure rates were 97% vs 95% while adverse events rose in the days following treatment in 33% vs 70%, usual symptoms with praziquantel being headache, nausea, dizziness, fatigue and abdominal cramps; no mention of ALT elevations or hepatotoxicity).
Hong ST. (2018). Albendazole and praziquantel: review and safety monitoring in Korea. Infect Chemother. (Korean registry of adverse event reports made between 2006 and 2015 included 108 praziquantel events which were usually mild and transient gastrointestinal and neurologic symptoms, with one report of abnormal liver tests; no details provided).
McManus DP, Dunne DW, Sacko M, Utzinger J, Vennervald BJ, Zhou XN. (2018). Schistosomiasis. Nat Rev Dis Primers. (Extensive review of the pathogenesis, epidemiology, clinical course, complications and management of schistosomiasis mentions that praziquantel is the most effective and widely used therapy, is active against all Schistosoma species, but only against adult worms for which reason it does not prevent reinfection and can give rise to drug resistance; praziquantel has transient, mild adverse events most of which are attributable to worm release rather than direct effects of the drug).
Shindo T, Masuda Y, Imai Y, Nagano T, Nishioka H. (2019). Case Report: Acute generalized exanthematous pustulosis caused by praziquantel. Am J Trop Med Hyg. (30 year old man developed fever and rash the day after a single dose of praziquantel with abnormal liver tests [bilirubin 1.5 mg/dL, ALT 841 U/L, Alk P 468 U/L], symptoms resolving over the next week with normal tests 16 days later).
Darko SN, Hanson H, Twumasi-Ankrah S, Baffour-Awuah S, Adjei-Kusi P, Yar D, Owusu-Dabo E. (2020). Three monthly doses of 60 mg/kg praziquantel for Schistosoma haematobium infection is a safe and effective treatment regimen. BMC Infect Dis. (Therapy of 28 patients with S. haematobium infection with 3 monthly doses of praziquantel was highly effective and serum ALT, AST and GGT levels during the 3 months were no different than levels in 53 control subjects followed concurrently).

## OTHER REFERENCE LINKS

1 Recent References on Praziquantel: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Praziquantel/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Praziquantel: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Praziquantel)